# Horny Goat Weed

## OVERVIEW

### Introduction

Horny goat weed is a low growing plant with leathery leaves found in wetlands in many areas of the world, extracts of which have been used in traditional medicine as a tonic, aphrodisiac and antirheumatic agent. Oral forms of horny goat weed have been not been linked to serum aminotransferase elevations or to instances of clinically apparent liver injury.

### Background

Horny goat weed is a member of the genus Epimedium, a low growing perennial plant found throughout Asia, and parts of Europe and Africa, which has been used in traditional medicine for centuries as a tonic, aphrodisiac and antirheumatic agent. Extracts of the leaves and stems of horny goat weed are purported to have activity in improving sexual dysfunction, menstrual irregularities, osteoporosis, asthma, nephritis and cardiovascular disease. Over 200 chemical constituents have been identified in the plant, among which are flavonoids, lignans, ionones, phenol glycosides and sesquiterpenes. The active ingredients that have antiinflammatory, immunomodulatory, antiviral and hepatoprotective activities are believed to be flavonoids, such as icariin, icaritin or epimedin. Clinical studies of extracts of Epimedium have shown promising effects in the treatment of high blood pressure, coronary artery disease and sexual satisfaction, but these effects have not been proven in rigorous prospective controlled trials. Horny goat weed is available in multiple forms in tablets and capsules of 250 or 500 mg, the usual dose being one tablet or capsule daily. Horny goat weed is often combined with other botanicals, the combinations dictated by the purported use. Horny goat weed is generally well tolerated without adverse events; minor side effects may include abdominal discomfort and nausea. Rare instances of hypersensitivity reactions, skin rash and allergic dermatitis have been described.

### Hepatotoxicity

In small clinical trials of horny goat weed, serum enzyme elevations and episodes of acute liver injury have not been reported. There have, however, been rare reports of liver injury in patients taking multi-ingredient products that contain epimedium, although the attribution of injury to horny goat weed has not always been very clear. In large registries and case series on drug and herbal product induced liver injury, horny goat weed has not been listed. Furthermore, cases of severe clinically apparent liver injury has not been reported with horny goat weed.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Horny goat weed has several hundred chemical constituents, none of which has been shown to be particularly toxic or to cause liver injury.

Other names: Bishop’s hat, fairy wings, rowdy lamb herb, barrenwort, Yin Yang Huo

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Horny goat weed – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at MedlinePlus, NLM (https://medlineplus.gov/druginfo/natural/699.html)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Horny Goat Weed | E700000000 | Herbal | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 08 August 2022

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not horny goat weed).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of horny goat weed).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbals, including discussion of potential risk factors, and herb-drug interactions).
Estes JD, Stolpman D, Olyaei A, Corless CL, Ham JM, Schwartz JM, Orloff SL. (2003). High prevalence of potentially hepatotoxic herbal supplement use in patients with fulminant hepatic failure. Arch Surg. (Among 20 patients undergoing liver transplantation for acute liver failure during 2001-2, 10 were potentially caused by herbals, but none attributed to horny goat weed).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found none attributable to horny goat weed).
Metz D, Weston P, Barker D. Case report of vasculitic rash induced by Ginkgo biloba and/or Horny Goat Weed. BMJ Case Rep. 2009;2009:bcr07.2008.0399. (77 year old man developed a painful maculopapular rash 4 days after starting a herbal remedy containing Ginkgo biloba and horny goat weed; “liver function tests” were normal).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not horny goat weed).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; horny goat weed is not discussed).
Ma H, He X, Yang Y, Li M, Hao D, Jia Z. (2011). The genus Epimedium: an ethnopharmacological and phytochemical review. J Ethnopharmacol. (Horny goat weed is a genus of 52 species [Epimedium], the stems and leaves of which are used in traditional medicine as a tonic, aphrodisiac and antirheumatic).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements but does not list or mention horny goat weed).
Punyawudho B, Puttilerpong C, Wirotsaengthong S, Aramwit P. (2012). A randomized, double-blind, placebo-controlled crossover study of Cappra® for the treatment of mild or mild to moderate erectile dysfunction in Thai male. Afr J Tradit Complement Altern Med. (Controlled crossover trial of Cappra [5 ingredients including Epimedium] vs placebo for 2 weeks in 63 men with mild to moderate erectile dysfunction found slight improvements in erectile dysfunction with Cappra, and adverse events of tachycardia, dizziness and facial numbness but no changes in ALT or AST).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing horny goat weed).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury; does not mention horny goat weed).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Nishimatsu H, Kitamura T, Yamada D, Nomiya A, Niimi A, Suzuki M, Fujimura T, et al. (2014). Improvement of symptoms of aging in males by a preparation LEOPIN ROYAL containing aged garlic extract and other five of natural medicines – comparison with traditional herbal medicines (Kampo). Aging Male. (Controlled trial of “Leopin Royal” [garlic, ginseng, bezoar, velvet antler, cuscuta seed and epimedium] vs Kampo [as a control] in 49 elderly men for 6 months found no differences in changes in sexual function scales, or on testosterone, FSH, LH or estradiol levels between the two groups; adverse events of the herbal remedy included epigastric discomfort and rash).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products but none were listed as containing horny goat weed).
Navarro VJ, Lucena MI. (2014). Hepatotoxicity induced by herbal and dietary supplements. Semin Liver Dis. (Review of the international regulatory framework for HDS products and the epidemiology, clinical presentation, diagnosis and cause of HDS associated liver injury with tables and discussion of the most commonly implicated agents, but does not include mention of horny goat weed).
Cui T, Kovell RC, Brooks DC, Terlecki RP. (2015). A urologist's guide to ingredients found in top-selling nutraceuticals for men's sexual health. J Sex Med. (Description and assessment of over-the-counter nutraceuticals used for male sexual dysfunction includes a discussion of horny goat weed for which there is a dearth of evidence of any activity).
Seeff LB, Bonkovsky HL, Navarro VJ, Wang G. (2015). Herbal products and the liver: a review of adverse effects and mechanisms. Gastroenterology. (Extensive review of herbal associated liver injury does not discuss horny goat weed).
Dietz BM, Hajirahimkhan A, Dunlap TL, Bolton JL. (2016). Botanicals and their bioactive phytochemicals for women's health. Pharmacol Rev. (Review of botanicals used to treat premenstrual syndrome, urinary tract infections, nausea of pregnancy, lactation, menopausal symptoms and breast cancer; horny goat weed has been used to enhance libido in men and women and alleviating symptoms of menopause and premenstrual syndrome, the active ingredient likely being icaritin which appears to have estrogenic bioactivity).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, lists none as due to horny goat weed).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while none were attributed to horny goat weed).
Balasubramanian A, Thirumavalavan N, Srivatsav A, Yu J, Hotaling JM, Lipshultz LI, Pastuszak AW. (2019). An analysis of popular online erectile dysfunction supplements. J Sex Med. (Horny goat weed is listed among the top 6 most frequently marketed supplements used for erectile dysfunction).
Kuchakulla M, Narasimman M, Soni Y, Leong JY, Patel P, Ramasamy R. (2021). A systematic review and evidence-based analysis of ingredients in popular male testosterone and erectile dysfunction supplements. Int J Impot Res. (Among 37 ingredients used to treat male sexual dysfunction, most frequent are Tribulus, Eurycoma longifolia, zinc, L-arginine, horny goat weed and yohimbe; horny goat weed has some evidence of efficacy but “must be viewed with caution”).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while none was attributed to horny goat weed).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62], and greater celandine [48]; none was attributed to horny goat weed or epimedium).

## OTHER REFERENCE LINKS

1 Recent References on Horny Goat Weed: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=horny+goat+weed+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Horny Goat Weed: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=horny%20goat%20weed)